# Tafenoquine

## OVERVIEW

### Introduction

Tafenoquine is an aminoquinoline that is used in combination with other antimalarials for the prevention of relapse of Plasmodium vivax malaria and by itself as prophylaxis against all species of malaria. Tafenoquine has been linked to low rates of transient and asymptomatic serum enzyme elevations during therapy but has not been associated with instances of clinically apparent acute liver injury.

### Background

Tafenoquine (ta fen' oh kwin) is a synthetic 8-aminoquinoline that acts by binding to the protozoal or parasitic DNA and preventing DNA and RNA production and subsequent protein synthesis; it is active against several of the stages in the development of the plasmodia including liver schizonts, hypnozoites and gametocytes and has most activity against Plasmodium vivax. Tafenoquine was shown to decrease the risk of relapse in patients with Plasmodium vivax malaria who were treated with chloroquine but was less effective than current regimens when used as monotherapy for P. vivax malaria. Tafenoquine has also been shown to be effective as prophylaxis against malaria in travelers to regions with a high risk of malaria transmission. Tafenoquine was approved for use in the United States in 2018 for use in combination with other antimalarials such as chloroquine in prevention of relapse of P. vivax malaria, also referred to as “radical cure”. For this indication, tafenoquine is available as tablets of 150 mg under the brand name Krintafel and the recommended regimen is a single oral dose of 300 mg (2 tablets) given on day 1 or 2 of standard therapy of P. vivax malaria. Later in 2018, tafenoquine was approved for use as prophylaxis against malaria in travelers to high risk areas. For malarial prophylaxis, tafenoquine is available as 100 mg tablets under the brand name Arakoda, and the recommended regimen is a loading dose of 200 mg daily for three days before travel and maintenance dose of 200 mg once weekly to continue until one week after return from travel. Common side effects of tafenoquine include headache, dizziness, anorexia, nausea, pruritus and a decrease in hemoglobin. Testing for G6PD is recommended before using tafenoquine as it can induce hemolysis and methemoglobinemia in patients with G6PD deficiency. Other potentially severe but rare side effects include hypersensitivity reactions and severe psychiatric effects. Specific recommendations on the therapy and prevention of malaria including regularly updated details on diagnosis, drug dosage and safety are available at the CDC website: http://www.cdc.gov/malaria/.

### Hepatotoxicity

In prelicensure clinical trials, tafenoquine was linked to a low rate of transient and mild serum aminotransferase elevations during therapy, but not to serum enzyme elevations with jaundice or with clinically apparent acute liver injury. It has had limited widescale use but appears to have a low risk for hepatotoxicity, and its safety profile has been similar to that of primaquine. Tafenoquine can cause hemolysis in patients with G6PD deficiency, which can result in mild indirect hyperbilirubinemia and jaundice, but without significant accompanying evidence of liver injury.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Hepatic reactions to aminoquinolines used for treatment and prevention of malaria are usually due to hypersensitivity reactions but have been not been reported with tafenoquine. Tafenoquine has minimal hepatic metabolism and has not been found to have clinically significant drug-drug interactions.

### Outcome and Management

There is little information on the susceptibility to hepatic injury among the various antimalarial agents, but caution should be used in switching to other aminoquinolines after clinically apparent liver injury to another member of this class.

Drug Class: Antimalarial Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Tafenoquine – Arakoda®, Krintafel®

DRUG CLASS

Antimalarial Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Primaquin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Tafenoquine | 106635-80-7 | C24-H28-F3-N3-O3 | Chemical Structure for Tafenoquine

## ANNOTATED BIBLIOGRAPHY

References updated: 10 April 2019

Abbreviations used: P. vivax, Plasmodium vivax; G6PD, glucose-6-phosphate dehydrogenase.

Zimmerman HJ. Antiprotozoal agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 623-5. (Expert review of hepatotoxicity published in 1999 before the availability of tafenoquine).
Vinetz JM. Chemotherapy of malaria. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 969-86. (Textbook of pharmacology and therapeutics).
https://www.accessdata.fda.gov/scripts/cder/daf/ (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA scientific review of the new drug application for safety and efficacy).
Llanos-Cuentas A, Lacerda MV, Rueangweerayut R, Krudsood S, Gupta SK, Kochar SK, Arthur P, et al. Tafenoquine plus chloroquine for the treatment and relapse prevention of Plasmodium vivax malaria (DETECTIVE): a multicentre, double-blind, randomised, phase 2b dose-selection study. Lancet 2014; 383 (9922): 1049-58. (Among 329 patients with P. vivax malaria treated with chloroquine combined with tafenoquine [50, 100, 300 or 600 mg] vs chloroquine with primaquine vs chloroquine alone, relapse free efficacy was greater with the higher doses of tafenoquine [89% and 92%] than with lower doses [58% and 54%] or with chloroquine alone [38%], while adverse event rates were similar including ALT elevations [2-7% in tafenoquine vs 2-8% in chloroquine groups]. 24360369
Price RN, Nosten F. Single-dose radical cure of Plasmodium vivax: a step closer. Lancet 2014; 383 (9922): 1020-1. (Editorial in response to Llanos-Cuentas [2014]). 24360370
Dow GS, Liu J, Lin G, Hetzell B, Thieling S, McCarthy WF, Tang D, et al. Summary of anti-malarial prophylactic efficacy of tafenoquine from three placebo-controlled studies of residents of malaria-endemic countries. Malar J 2015; 14: 473. (The protective efficacy of tafenoquine vs mefloquine in preventing malaria among Australian soldiers deployed to East Timor in 2000/2001 was estimated to be 100% for both regimens). 26610844
Fukuda MM, Krudsood S, Mohamed K, Green JA, Warrasak S, Noedl H, Euswas A, et al. A randomized, double-blind, active-control trial to evaluate the efficacy and safety of a three-day course of tafenoquine monotherapy for the treatment of Plasmodium vivax malaria. PLoS One 2017; 12: e0187376. (Among 65 patients with P. vivax malaria treated with 3 days of tafenoquine vs chloroquine with primaquine, adverse events linked to tafenoquine included methemoglobinemia in 48% vs 0% and “abnormal hepatic enzymes” in 4% vs 0%, but no patient was symptomatic). 29121061
Novitt-Moreno A, Ransom J, Dow G, Smith B, Read LT, Toovey S. Tafenoquine for malaria prophylaxis in adults: An integrated safety analysis. Travel Med Infect Dis 2017; 17: 19-27. (Analysis of adverse event rates reported from 5 clinical trials of tafenoquine prophylaxis against malaria; mentions that adverse events occurring more frequently with tafenoquine [n=825] than placebo [n=295] included diarrhea, gastroenteritis, nausea, vomiting, upper respiratory symptoms and back or neck pain; no mention of ALT elevations or hepatotoxicity). 28495354
Rueangweerayut R, Bancone G, Harrell EJ, Beelen AP, Kongpatanakul S, Möhrle JJ, Rousell V, et al. Hemolytic potential of tafenoquine in female volunteers heterozygous for glucose-6-phosphate dehydrogenase (G6PD) deficiency(G6PD Mahidol variant) versus G6PD-normal volunteers. Am J Trop Med Hyg 2017; 97: 702-11. (Dose escalating study of single doses of tafenoquine [100 to 300 mg] in women with mild G6PD deficiency and normal controls found hemoglobin declines with all doses and dose-limiting toxicity at 200 and 300 mg). 28749773
Baird JK. Tafenoquine for travelers' malaria: evidence, rationale and recommendations. J Travel Med 2018; 25 (1): 1-13. (Extensive review of the role of tafenoquine as chemoprophylaxis against malaria). 30380095
Frampton JE. Tafenoquine: first global approval. Drugs 2018; 78: 1517-23. (Review of the history of development, structure, pharmacology, clinical efficacy and safety of tafenoquine both as treatment of P. vivax malaria [combined with chloroquine] and prophylaxis in travelers against malaria [used alone]; mentions that laboratory abnormalities during treatment can include increased aminotransferase levels). 30229442
Lacerda MVG, Llanos-Cuentas A, Krudsood S, Lon C, Saunders DL, Mohammed R, Yilma D, et al. Single-dose tafenoquine to prevent relapse of plasmodium vivax malaria. N Engl J Med 2019; 380: 215-28. (Among 522 patients with P. vivax infection treated with chloroquine [3 days] with or without tafenoquine [single dose] or primaquine [14 days], relapses were more common with placebo than tafenoquine or primaquine and adverse event rates were similar in all groups, with no differences in "laboratory outcomes"). 30650322
Llanos-Cuentas A, Lacerda MVG, Hien TT, Vélez ID, Namaik-Larp C, Chu CS, Villegas MF, et al. Tafenoquine versus primaquine to prevent relapse of plasmodium vivax malaria. N Engl J Med 2019; 380: 229-41. (Among 640 patients with P. vivax infection treated with chloroquine and either tafenoquine [single 300 mg dose] vs primaquine [15 mg once daily for 14 days], relapse free outcome was 67% vs 73% and adverse event rates were similar, ALT elevations occurring in 2% vs 3%, none of which were above 5 times ULN or associated with symptoms and jaundice). 30650326

## OTHER REFERENCE LINKS

1. Recent References on Tafenoquine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=primaquine+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Tafenoquine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=primaquine)